# Ciprofloxacin

## OVERVIEW

### Introduction

Ciprofloxacin is a second generation fluoroquinolone antibiotic that is widely used in the therapy of mild-to-moderate urinary and respiratory tract infections caused by susceptible organisms. Ciprofloxacin has been linked to rare but convincing instances of liver injury that can be severe and even fatal.

### Background

Ciprofloxacin (sip" roe flox' a sin) is an oral fluoroquinolone that is used to treat mild-to-moderate urinary and respiratory tract infections. Ciprofloxacin is also used for infectious diarrhea, typhoid fever, uncomplicated gonorrhea, treatment of Neisseria meningitides nasal carriage and prophylaxis against anthrax. Like other fluoroquinolones, ciprofloxacin is active against a wide range of aerobic gram-positive and gram-negative organisms. The fluoroquinolones are believed to act by inhibition of bacterial DNA gyrase and topoisomerase IV that are required for synthesis of bacterial mRNAs (transcription) and DNA replication. In contrast, DNA gyrases are not present in human [and other eukarotic] cells and the equivalent topoisomerases are not sensitive to fluoroquinolone inhibition. Ciprofloxacin was approved for use in the United States in 1990 and, currently, more than 4 million prescriptions are filled yearly. Ciprofloxacin is available in multiple oral formulations of 100, 250, 500 and 750 mg tablets and extended release formulations of 500 and 1000 mg tablets. Ciprofloxacin is available generically and under several commercial names including Cipro and Proquin. The usual oral dose is 250 to 500 mg every 12 hours. Oral formulations are recommended for mild-to-moderate infections due to susceptible organisms, including urinary tract infections, sinusitis, bronchitis, skin infections, urethral and cervical infections. Intravenous formulations are available for moderate to severe infections, including pneumonia, sinusitis, septicemia, intraabdominal and bone and joint infections, the usual dosages being 200 to 400 mg intravenously every 8 hours. Oral therapy is typically continued for 7 to 10 days, but both shorter and longer courses are used. Common side effects include gastrointestinal upset, headaches, skin rash and allergic reactions. Less common, but more severe side effects include prolongation of the QT interval, seizures, hallucinations, tendon rupture, angioedema, Stevens Johnson syndrome and photosensitivity. Because of the frequency of severe adverse events, fluoroquinolones should not be used as first line therapy of mild and moderate infections.

### Hepatotoxicity

Ciprofloxacin like other fluoroquinolones is associated with a low rate (1% to 3%) of serum enzyme elevations during therapy. These abnormalities are generally mild, asymptomatic and transient, resolving even with continuation of therapy. More importantly, ciprofloxacin has been linked to rare, but occasionally severe and even fatal cases of acute liver injury. The time to onset is typically short (2 days to 2 weeks) and the presentation is often abrupt with nausea, fatigue and abdominal pain, followed by dark urine and jaundice. The pattern of serum enzyme elevations can be either hepatocellular or cholestatic; cases with the shorter times to onset usually being more hepatocellular with markedly elevated ALT levels, and occasionally with rapid worsening of prothrombin time and early signs of hepatic failure. The onset of illness also may occur a few days after the medication is stopped. Cases with a cholestatic pattern of enzymes may run a prolonged course, but are usually self-limiting. Nevertheless, chronic cholestasis and vanishing bile duct syndrome have been reported with ciprofloxacin and other fluoroquinolones. Finally, the enzyme pattern can be initially hepatocellular and then evolve during the course of illness from a hepatocellular into a mixed or cholestatic pattern. Many (but not all) cases have had allergic manifestations with fever, rash and eosinophilia. Autoantibodies are usually not present.

Likelihood score: A (well established but uncommon cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of ciprofloxacin hepatotoxicity is suspected to be hypersensitivity. Rechallenge leads to recurrence with a shorter time to onset and more severe course and should be avoided.

### Outcome and Management

Severity ranges from mild and transient serum enzyme elevations to a self-limited hepatitis, to prolonged cholestatic hepatitis to a fulminant hepatic failure. If not fatal during the acute phase, complete recovery is expected after stopping the drug and is usually rapid (2 to 4 weeks) depending upon the severity and degree of cholestasis. Some instances of cholestatic liver injury from ciprofloxacin have resulted in vanishing bile duct syndrome. Corticosteroids have been used with variable degrees of success. Cross reactivity of the hepatic injury between different fluoroquinolones has been demonstrated in a small number of cases, but should be assumed based upon the similarity of clinical patterns of injury and latency. Thus, patients should be advised to avoid further exposure to the fluoroquinolones.

Drug Class: Antiinfective Agents

Other Drugs in the Subclass, Fluoroquinolones: Delafloxacin, Gemifloxacin, Levofloxacin, Moxifloxacin, Norfloxacin, Ofloxacin

## CASE REPORTS

### Case 1. Cholestatic hepatitis due to ciprofloxacin therapy.(1)

An 84 year old female resident of a long term care facility received a course of ciprofloxacin for urinary tract infection. Six days later she was found to have a rash and ciprofloxacin was stopped. Nevertheless, 3 days after stopping she was noted to be jaundiced. Serum bilirubin rose to as high as 8.2 mg/dL, but she recovered within 6 weeks.

#### Key Points

Medication: | Ciprofloxacin, 500 mg daily for 6 days
Pattern: | Cholestatic (R=0.2)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 6 days
Recovery: | Approximately 6 weeks
Other medications: | Cefoperazone IV for 6 days before starting ciprofloxacin; and docusate/casanthranol, lorazepam and acetaminophen chronically as needed.

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
Pre | | 20 | 158 | 0.5
6 days | 0 | Ciprofloxacin stopped because of rash
9 days | 3 days | 64 | 1119 | 7.8 | No eosinophilia
12 days | 6 days | 126 | 1411 | 8.2 | Abdominal ultrasound normal
3 weeks | 2 weeks | 60 | 866 | 2.7
5 weeks | 4 weeks | 15 | 317 | 1.5
6 weeks | 5 weeks | 23 | 201 | 1.0
3.5 months | | | 115 | 0.6
Normal Values | | <41 | <115 | <1.2

* Converted from µmol/L.

#### Comment

This patient received multiple medications, but the timing of onset and pattern of injury was typical of fluoroquinolone induced liver injury with short latency and rapid recovery upon withdrawal. The cholestatic pattern of injury is somewhat atypical, but occurs when the jaundice is severe and prolonged, particularly in the elderly. The lack of blood tests at earlier time points precludes a full assessment of the enzyme response which may have been more hepatocellular at onset of symptoms. Interestingly, this patient had received two previous courses of ciprofloxacin and was said to be allergic to sulfonamides.

### Case 2. Severe acute hepatitis due to ciprofloxacin therapy.(2)

An 80 year old female developed nausea, anorexia and increasing forgetfulness followed by jaundice starting the week after completing a 10 day course of ciprofloxacin (500 mg twice daily) and while taking metronidazole (250 mg twice daily). She had a past medical history of hypertension, congestive heart failure, atrial fibrillation, colonic polyps and depression. Her other medications included furosemide, atenolol, valsartan, warfarin, vitamins and ginkgo biloba. She also took occasional acetaminophen with or without oxycodone for pain. She had no history of liver disease or risk factors for viral hepatitis and did not drink alcohol. Two months before onset of jaundice, she had developed diarrhea and abdominal pain which was presumed to be diverticulitis and for which she was given the two antibiotics. During the week before admission, she had increasing fatigue and forgetfulness and the day before presentation developed pruritus, dark urine and jaundice. Physical examination was unremarkable except for jaundice. She did not have fever, rash, hepatomegaly, splenomegaly, ascites or asterixis. Laboratory testing showed total bilirubin of 9.6 mg/dL (direct 6.8 mg/dL), ALT 705 U/L and INR 8.2 (Table). There was mild eosinophilia. Serum antinuclear antibody was negative, smooth muscle antibody was weakly positive (1:20). She was admitted and all medications including warfarin were stopped. Because of concern over acute liver failure, she was transferred to a tertiary care hospital for management. Tests for hepatitis A, B and C (including HCV RNA) were negative as were tests for Epstein Barr virus and cytomegalovirus infection. CT scans showed mild hepatosplenomegaly, mild ascites, absence of a gall bladder and no evidence of biliary obstruction. A liver biopsy showed severe acute hepatitis with giant cells and bridging necrosis. She developed worsening jaundice, ascites, and hepatic encephalopathy and died of multiorgan failure 5 weeks after onset of jaundice.

#### Key Points

Medication: | Ciprofloxacin, 500 mg daily for 10 days
Pattern: | Hepatocellular (R=11.1)
Severity: | 5+ (death from acute liver failure)
Latency: | 18 days (5 days after stopping medication)
Recovery: | None
Other medications: | Metronidazole for previous 18 days; warfarin, atenolol, valsartan, furosemide chronically

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
18 | 8 | 388 | .. | .. | INR 8.2. Admitted
20 | 10 | 723 | 114 | 9.6
22 | 12 | 1684 | 133 | 12.2 | Transferred
24 | 14 | 1536 | 130 | 14.5 | INR 2.1
26 | 16 | 1406 | 136 | 18.2
28 | 18 | 1157 | 122 | 21.1 | INR 4.5
58 | 48 | Patient died of multiorgan failure
Normal Values | | <65 | <135 | <1.2

#### Comment

An example of acute hepatocellular injury attributed to ciprofloxacin. Metronidazole can also cause acute hepatocellular injury and acute liver failure, but such cases are exceedingly rare. In contrast, the precipitous onset and relatively short latency are typical of fluoroquinolone induced acute liver injury. Also, ciprofloxacin induced liver injury tends to be more common and more severe in the elderly.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ciprofloxacin – Generic, Cipro®, Proquin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ciprofloxacin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Ciprofloxacin HCl | 86393-32-0 | C17-H18-F-N3-O3.Cl-H.H2-O

## CITED REFERENCES

1 Sherman O, Beizer JL. Possible ciprofloxacin-induced acute cholestatic jaundice. Ann Pharmacother 1994; 28: 1162-4.7841570
2 Orman ES, Conjeevaram HS, Vuppalanchi R, Freston JW, Rochon J, Kleiner DE, Hayashi PH; DILIN Research Group. Clinical and histopathologic features of fluoroquinolone-induced liver injury. Clin Gastroenterol Hepatol 2011; 9: 517-23.e3.21356330

## ANNOTATED BIBLIOGRAPHY

References updated: 09 May 2024

Abbreviations used: SJS, Stevens Johnson syndrome; TEN, toxic epidermal necrolysis.

Zimmerman HJ. Quinolones. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p 603. (Expert review of hepatotoxicity published in 1999 mentions that cinoxacin, nalidixic acid, ciprofloxacin, norfloxacin, enoxacin, and ofloxacin are associated with minor serum enzyme elevations during therapy and with rare instances of clinically apparent liver injury).
Moseley RH. Fluoroquinolones. Hepatotoxicity of antimicrobial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 468-9. (Review of hepatotoxicity of antibiotics mentions that hepatocellular and cholestatic forms of injury have been reported due to the quinolones, including cases of ductopenia, acute liver failure and death).
MacDougall C. The quinolones. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1015-8. (Textbook of pharmacology and therapeutics).
Halkin H. Adverse effects of the fluoroquinolones. Rev Infect Dis 1988; 10 (Suppl 1): S258-61. (Combined analysis of databases provided by manufacturers on adverse events of fluoroquinolones in approximately 30,000 persons receiving ciprofloxacin, ofloxacin, pefloxacin, norfloxacin and enoxacin found similar types and rates of adverse events among the agents, overall in 4-8%, elevated liver enzymes in 1.8-2.5%, but eosinophilia in 2.4% with ciprofloxacin and 5-19% with ofloxacin). 3279499
Arcieri GM, Becker N, Esposito B, et al. Safety of intravenous ciprofloxacin. A review. Am J Med 1989; 87 (Suppl 5A): 92S-97S. (Summary on safety of intravenous ciprofloxacin based upon 1869 patients treated in 59 clinical trials; ALT elevations occurred in 2.0% and one patient had "hepatic necrosis"). 2686431
Kljucar S, Heimesaat M, von Pritzbuer E, Timm J, Scholl H, Beermann D. Efficacy and safety of higher-dose intravenous ciprofloxacin in severe hospital-acquired infections. Am J Med 1989; 87: 52S-56S. (Elevated ALT levels occurred in 7 of 54 patients given high dose intravenous ciprofloxacin; no symptomatic hepatotoxicity). 2589385
Schacht P, Arcieri G, Hullmann R. Safety of oral ciprofloxacin. An update based on clinical trial results. Am J Med 1989; 87 (Suppl 5A): 98S-102S. (Industry report on 9473 courses of oral ciprofloxacin, usually given for 7-14 days: 9.3% had an adverse event, mostly mild, only 0.5% were serious. ALT elevations occurred in 1.3%, but jaundice in only 1 patient). 2686432
Slama TG. Serum sickness-like illness associated with ciprofloxacin. Antimicrob Agents Chemother 1990; 34: 904-5. (56 year old man developed rash, fever, arthralgias and eosinophilia after 6 days of ciprofloxacin accompanied by mild enzyme elevations [bilirubin normal, ALT 102-307 U/L, Alk P 128-178 U/L], resolving rapidly with corticosteroid therapy). 2360826
Wolfson JS, Hooper DC. Overview of fluoroquinolone safety. Am J Med 1991; 91 (Suppl 6A): 153S-61S. (Review of side effects reported in 22 clinical trials of fluoroquinolones; elevations in ALT and/or Alk P levels occurred in 1.8-2.7% of patients on cipro-, nor-, or ofloxacin). 1767803
Grassmick BK, Lehr VT, Sundareson AS. Fulminant hepatic failure possibly related to ciprofloxacin. Ann Pharmacother 1992; 26: 636-9. (66 year old man developed symptoms and jaundice after 1 day of starting ciprofloxacin [bilirubin 10.9 mg/dL, ALT 2608 U/L, Alk P 269 U/L] with shock, lactic acidosis and death 7 days later). 1591420
Jick SS, Jick H, Dean AD. A follow-up safety study of ciprofloxacin users. Pharmacotherapy 1993; 13: 461-4. (Follow up of ~37,000 patients for 45 days after receiving oral ciprofloxacin, none developed clinically apparent liver disease). 8247912
Levinson JR, Kumar A. Ciprofloxacin induced cholestatic jaundice: a case report. Am J Gastroenterol 1993; 88: 1619. (Abstract: 46 year old woman developed pruritus and jaundice within a few days of starting ciprofloxacin [bilirubin 10.6 mg/dL, ALT 519 U/L, Alk P 1459 U/L], resolving several weeks after stopping).
Fuchs S, Simon Z, Brezin M. Fatal hepatic failure associated with ciprofloxacin. Lancet 1994; 343: 738-9. (92 year old man developed "progressive hepatic failure" after 2 days of IV ciprofloxacin; no details given). 7907714
Sherman O, Beizer JL. Possible ciprofloxacin-induced acute cholestatic jaundice. Ann Pharmacother 1994; 28: 1162-4. (84 year old woman developed jaundice and rash after 7 days of ciprofloxacin therapy [bilirubin 8.2 mg/dL, ALT 126 U/L, Alk P 1119 U/L, resolving over ensuing 6 weeks: Case 1). 7841570
Ball P, Tillotson G. Tolerability of fluoroquinolone antibiotics. Past, present and future. Drug Saf 1995; 13: 343-58. (Review of the nature and frequency of adverse reactions to the fluoroquinolones mentions that clinically apparent liver injury is rare, but that severe and occasional fatal cases have been reported with ciprofloxacin, levofloxacin, norfloxacin and ofloxacin and from postmarketing surveillance has estimated the frequency of clinically apparent liver injury to be 0.8 per 100,000 recipients). 8652079
Aggarwal A, Gurka J. Probable ciprofloxacin induced cholestasis. Aust N Z J Med 1995; 25: 541-2. (36 year old man developed marked Alk P elevations [peak 792 U/L] with minimal increases in ALT [61 U/L], without symptoms or jaundice within a week of starting ciprofloxacin, falling to baseline within 6 weeks of stopping). 8588783
Alcalde M, Donoso MS, Carcfa-Diaz M, Pascasio JM, Narvaez I. Liver dysfunction due to ciprofloxacin. Acta Gastroenterol Belg 1995; 58: 475-6. (27 year old man developed fatigue after 10 days of ciprofloxacin therapy [bilirubin 2.5 mg/dL, ALT 248 U/L, Alk P not available], resolving within 2 months of stopping). 8776005
Hautekeete ML, Kockx MM, Naegels S, Holvoet JK, Hubens H, Kloppel G. Cholestatic hepatitis related to quinolones: a report of two cases. J Hepatol 1995; 23: 759-60. (50 year old man developed fatigue after 5 days of oral ciprofloxacin [bilirubin 4.8 rising to 9.3 mg/dL, ALT 202 U/L, Alk P 314 U/L], resolving within 9 weeks of stopping; second case due to ofloxacin). 8750178
Villeneuve JP, Davies C, Côté J. Suspected ciprofloxacin-induced hepatotoxicity. Ann Pharmacother 1995; 29: 257-9. (44 year old woman developed jaundice 2 weeks after finishing a 7 day course of ciprofloxacin [bilirubin 9.6 mg/dL, ALT 745 U/L, Alk P 284 U/L], with full recovery requiring 5 months). 7606070
Labowitz JK, Silverman WB. Cholestatic jaundice induced by ciprofloxacin. Dig Dis Sci 1997; 42: 192-4. (47 year old man developed jaundice and pruritus within 2 days of starting ciprofloxacin [bilirubin 10 rising to 34 mg/dL, ALT 308 U/L, Alk P 163 U/L], resolving slowly to normal over next 12 weeks). 9009137
Jones SE, Smith RH. Quinolones may induce hepatitis. BMJ 1997; 314(7084): 869. (21 year old man developed jaundice following a 5 day course of ofloxacin and two doses of ciprofloxacin [bilirubin 5.7 rising to 8.2 mg/dL, AST 348 U/L, Alk P 321 U/L], worsening for 7 days and then resolving within 5 weeks of stopping). 9093098
Contreras MA, Luna R, Mulero J, Andreu JL. Severe ciprofloxacin-induced acute hepatitis. Eur J Clin Microbiol Infect Dis 2001; 20: 434-5. (32 year old man developed abdominal pain, fever and rash within 2 days of starting ciprofloxacin [bilirubin not given, ALT 147 rising to 2144 U/L, GGT 98 U/L], with subsequent signs of liver failure, but ultimate recovery after methylprednisolone therapy). 11476450
Morelli MS, O'Brien FX. Stevens-Johnson Syndrome and cholestatic hepatitis. Dig Dis Sci 2001; 46: 2385-8. (19 year old woman developed fever followed by rash and jaundice 4 days after starting ibuprofen and 2 days after starting metoclopramide and ketorolac [bilirubin 3.3 rising to 9.2 mg/dL, ALT 300 U/L, Alk P 409 U/L], with worsening fever and rash diagnosed as Stevens Johnson syndrome [SJS], resolving without corticosteroid therapy). 11713940
Bataille L, Rahier J, Geubel A. Delayed and prolonged cholestatic hepatitis with ductopenia after long-term ciprofloxacin therapy for Crohn's disease. J Hepatol 2002; 37: 696-9. (63 year old woman with Crohn disease developed jaundice while being treated with ciprofloxacin and ornidazole [a nitroimidazole derivative also linked to cases of cholestatic jaundice] for 6 months [bilirubin 3.4 rising to 8.1 mg/dL, ALT 740 U/L, Alk P 662 U/L], liver biopsy showing paucity of bile ducts, slowly resolving over the 8 months after discontinuation of both drugs). 12399240
Hällgren J, Tengvall-Linder M, Persson M, Wahlgren CF. Stevens-Johnson syndrome associated with ciprofloxacin: a review of adverse cutaneous events reported in Sweden as associated with this drug. J Am Acad Dermatol 2003; 49 (5 Suppl): S267-9. (31 and 33 year old women developed rash and oral ulcers diagnosed as SJS 2 and 8 days after starting ciprofloxacin [one with serum enzyme elevations without jaundice], and review of Swedish Drug Information System found 8 other cases of serious cutaneous reactions due to ciprofloxacin). 14576649
Goetz M, Galle PR, Schwarting A. Non-fatal acute liver injury possibly related to high-dose ciprofloxacin. Eur J Clin Microbiol Infect Dis 2003; 22: 294-6. (79 year old woman developed confusion and lactic acidosis within 2 days of starting iv ciprofloxacin [peak bilirubin 1.6 mg/dL, ALT 4878 U/L, Alk P 581 U/L, LDH 6111 U/L], resolving within 2 weeks). 12739107
Zaidi SA. Hepatitis associated with amoxicillin/clavulanic acid and/or ciprofloxacin. Am J Med Sci 2003; 325: 31-3. (80 year old man received both ciprofloxacin and amoxicillin/clavulanate, developing rash and eosinophilia within 1 week followed by self-limiting serum enzyme elevations without jaundice [bilirubin 1.9 mg/dL, ALT 972 U/L, Alk P 358 U/L]). 12544082
Zimpfer A, Propst A, Mikuz G, Vogel W, Terracciano L, Stadlmann S. Ciprofloxacin-induced acute liver injury: case report and review of literature. Virchows Arch 2004; 444: 87-9. (22 year old man developed jaundice 1 week after finishing a 7 day course of ciprofloxacin [bilirubin 16.9 mg/dL, ALT 890 U/L, Alk P 180 U/L], symptoms and liver test abnormalities resolving within a week of starting methylprednisolone). 14994731
Thakur BS, Jain AK, Sirkar S, Joshi G, Joshi R. Ciprofloxacin-induced cholestatic jaundice. Indian J Gastroenterol 2007; 26 (1): 51-2. (26 year old man developed rash and then jaundice within 5 days of starting ciprofloxacin [ALT 1700 U/L], with slow recovery by 6 months after onset). 17401251
Bhagirath KM. A case report of highly suspected ciprofloxacin-induced hepatotoxicity. Turk J Gastroenterol 2008; 19: 204-6. (39 year old woman developed jaundice 1 month after a 14 day course of ciprofloxacin and metronidazole [bilirubin 16.3 mg/dL, ALT 1406 U/L, Alk P 160 U/L, IRN 1.6], resolving within the next 3 months with prednisone therapy). 19115163
Dichiara AJ, Atkinson M, Goodman Z, Sherman KE. Ciprofloxacin-induced acute cholestatic liver injury and associated renal failure. Case report and review. Minerva Gastroenterol Dietol 2008; 54: 307-15. (65 year old man developed jaundice 6 days into a course of ciprofloxacin for cellulitis [bilirubin 8.5 rising to 25 mg/dL, ALT 157 U/L, Alk P 711 U/L], with concurrent renal failure, and slow but eventual recovery 5 months later). 18614979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, the fluoroquinolones accounting for 10 cases [3%], including 5 attributed to ciprofloxacin [ranking 8th], 4 to levofloxacin, and 1 to moxifloxacin). 18955056
Okan G, Yaylaci S, Peker O, Kaymakoglu S, Saruc M. Vanishing bile duct and Stevens-Johnson syndrome associated with ciprofloxacin treated with tacrolimus. World J Gastroenterol 2008; 14: 4697-700. (26 year old woman developed fever and rash 2 weeks after starting ciprofloxacin [bilirubin 4.1 rising to 34 mg/dL, ALT 326 U/L, Alk P 229 U/L], biopsies showing SJS and bile duct loss, and ultimately improving and recovery with ursodiol, prednisone and tacrolimus therapy). 18698687
Miftode E, Leca D, Luca V. [A severe case of infectious mononucleosis associated with ciprofloxacin and salazopyrin administration]. Rev Med Chir Soc Med Nat Iasi 2008; 112: 652-5. Romanian. (22 year old woman developed rash and severe hepatitis 32 days after starting sulfasalazine and 2 days after ciprofloxacin [bilirubin 36 mg/dL, ALT 488 U/L]). 20201247
Cholongitas E, Georgousaki C, Spyrou S, Dasenaki M. Ciprofloxacin-induced acute cholestatic hepatitis. Ann Hepatol 2009; 8: 400-1. (66 year old man developed liver enzyme elevations 3 days after starting intravenous ciprofloxacin [direct bilirubin 1.9, ALT 582 U/L, Alk P 1234 U/L], with worsening for 7 days and then resolving within 3 months of stopping). 20009146
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 1 was attributed to ciprofloxacin, but none to other fluoroquinolones). 20949552
Alan C, Koçoğlu H, Ersay AR, Ertung Y, Kurt HA. Unexpected severe hepatotoxicity of ciprofloxacine: two case reports. Drug Chem Toxicol 2011; 34(2): 189-91. (Two cases; 56 and 62 year old men developed liver injury 2 and 5 days after starting ciprofloxacin [bilirubin ~5.0 mg/dL, ALT 500 and 320 U/L, Alk P 152 and 132 U/L, prothrombin time 57 and 34 secs], both recovering rapidly upon stopping). 21314468
Orman ES, Conjeevaram HS, Vuppalanchi R, Freston JW, Rochon J, Kleiner DE, Hayashi PH; DILIN Research Group. Clinical and histopathologic features of fluoroquinolone-induced liver injury. Clin Gastroenterol Hepatol 2011; 9: 517-23.e3. (Among 679 cases of drug induced liver injury presenting between 2004 and 2010 at 8 US medical centers, 12 [1.8%] were attributed to fluoroquinolones including 6 cipro-, 4 moxi-, 1 levo-, and 1 gatifloxacin; average time to onset was 4 days [range 1-39], with both hepatocellular and cholestatic enzyme patterns, 7 with rash or fever, mortality limited to those with hepatocellular injury and jaundice; the pattern of hepatic injury appeared to be shared among the fluoroquinolones: Case 2). 21356330
Paterson JM, Mamdani MM, Manno M, Juurlink DN; Canadian Drug Safety and Effectiveness Research Network. Fluoroquinolone therapy and idiosyncratic acute liver injury: a population-based study. CMAJ 2012; 184: 1565-70. (In a population based study using Canadian health care databases, the risk of admission to hospital for acute liver injury was increased for persons who received a prescription for moxifloxacin or levofloxacin relative to clarithromycin, but not for ciprofloxacin). 22891208
Hayashi PH, Chalasani NP. Liver injury in the elderly due to fluoroquinolones: should these drugs be avoided? CMAJ 2012; 184: 1555-6. (Editorial in response to Paterson [2013] stressing the low absolute risk of liver injury from the fluoroquinolones [4-9 per 100,000 exposures]). 22891207
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci 2012; 27: 268-73. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 29 [5.1%] attributed to quinolones). 22379337
Harr T, French LE. Stevens-Johnson syndrome and toxic epidermal necrolysis. Chem Immunol Allergy 2012; 97: 149-66. (Review of the clinical features, epidemiology, genetics and pathogenesis of SJS and TEN). 22613860
Patel TK, Barvaliya MJ, Sharma D, Tripathi C. A systematic review of the drug-induced Stevens-Johnson syndrome and toxic epidermal necrolysis in Indian population. Indian J Dermatol Venereol Leprol 2013; 79: 389-98. (Systematic review of 10 case series of SJS/TEN from India identified 352 cases, among which 342 implicated a medication with most common being antimicrobials [37%], anticonvulsants [16%] and NSAIDs [16%]; fluoroquinolones accounted for 33 cases [10%], 4 of which were due to ciprofloxacin, 1 ofloxacin and 1 levofloxacin). 23619444
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to ciprofloxacin or other fluoroquinolones). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one due to trovafloxacin [acute liver failure], but none attributed to ciprofloxacin or other fluoroquinolones). 24552865
Alshammari TM, Larrat EP, Morrill HJ, Caffrey AR, Quilliam BJ, LaPlante KL. Risk of hepatotoxicity associated with fluoroquinolones: a national case-control safety study. Am J Health Syst Pharm 2014; 71: 37-43. (Retrospective analysis of Veterans Affairs patients receiving a fluoroquinolone [n=7862] found a higher relative risk of developing acute liver injury after receipt of ciprofloxacin compared to matched controls [adjusted odds ratio: OR=1.29], but not after receipt of levofloxacin [OR=1.16) or moxifloxacin [OR=0.98]). 24352180
Goldberg DS, Forde KA, Carbonari DM, Lewis JD, Leidl KB, Reddy KR, Haynes K, et al. Population-representative incidence of drug-induced acute liver failure based on an analysis of an integrated health care system. Gastroenterology 2015; 148: 1353-61.e3. (Analysis of Kaiser Permanente health care database from 2004 to 2011 identified 62 patients with suspected acute liver failure, 32 [52%] of whom had a presumed drug etiology, the most common being acetaminophen [18: 56%] and various herbal products [5: 16%], with single instances attributed to imatinib, simvastatin, leflunomide, isoniazid and valproate, but none to ciprofloxacin or other fluoroquinolones). 25733099
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 38 cases [4%] were attributed to fluoroquinolones, including 16 due to ciprofloxacin [the 8th most common prescription drug cause], 13 due to levofloxacin and 8 to moxifloxacin). 25754159
Moreno L, Sánchez-Delgado J, Vergara M, Casas M, Miquel M, Dalmau B. Recurrent drug-induced liver injury (DILI) with ciprofloxacin and amoxicillin/clavulanic. Rev Esp Enferm Dig 2015; 107: 767-8. (56 year old woman developed pruritus and dark urine 4 and jaundice 10 days after starting ciprofloxacin [bilirubin 9.5 mg, ALT 506 U/L, Alk P 455 U/L, eosinophils 10%, INR 0.98] and, after recovery, developed jaundice again 9 days after starting amoxicillin/clavulanate [bilirubin 8.5 mg/dL, ALT 692 U/L, Alk P 348 U/L, eosinophils 3%], no information on recovery). 26671593
Kaddu-Mulindwa D, Lammert F, Maßmann A, Link A. [Acute liver failure after ingestion of ciprofloxacin]. Dtsch Med Wochenschr 2016; 141: 1173-6. (23 year old woman developed nausea 1 day and jaundice 5 days after starting ciprofloxacin [bilirubin 10.8 mg/dL, ALT 3431 U/L, Alk P 152 U/L, INR 2.5], with severe but self-limiting course, resolving completely over the next 6 months). 27509349
Goldie FC, Brogan A, Boyle JG. Ciprofloxacin and statin interaction: a cautionary tale of rhabdomyolysis. BMJ Case Rep 2016; 2016. pii: bcr2016216048. (62 year old woman on long term simvastatin developed rhabdomyolysis 4 days after starting ciprofloxacin [bilirubin and Alk P not given, ALT 240 U/L, CPK 24524 U/L], resolving with stopping both drugs, ALT elevations likely due to muscle rather than liver injury). 27469384
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, Ghabril MS, et al.; U.S. Drug Induced Liver Injury Network Investigators. Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology 2017; 65: 1267-77. (Among 363 patients with drug induced liver injury who underwent liver biopsy, 26 [7%] had bile duct loss of whom 94% developed evidence of chronic liver injury suggestive of vanishing bile duct syndrome, 2 of which were due to fluoroquinolones, 1 moxifloxacin and 1 levofloxacin). 27981596
Comparison table: some systemic fluoroquinolones. Med Lett Drugs Ther 2018; 60: e57-e58. (Table comparing 4 fluoroquinolones [cipro-, levo-, dela- and moxifloxacin] mentions that ALT and AST elevations are a class adverse event). 29635268
Mavros MN, Theochari NA, Kyriakidou M, Economopoulos KP, Sava JA, Falagas ME. Fluoroquinolone-based versus β-lactam-based regimens for complicated intra-abdominal infections: a meta-analysis of randomised controlled trials. Int J Antimicrob Agents 2019; 53: 746-54. (Systematic review of controlled trials of fluoroquinolones versus β-lactam-based antibiotic regimens found similar rates of efficacy and adverse events, no discussion of ALT elevations or liver related toxicities). 30639629
Kuula LSM, Viljemaa KM, Backman JT, Blom M. Fluoroquinolone-related adverse events resulting in health service use and costs: A systematic review. PLoS One 2019; 14: e0216029. (Systematic review of observational studies on safety of fluoroquinolones concluded that due to lack of published literature, health service and costs could not be evaluated). 31026286
Napier DJ, Bevan AV, di Mambro A. A fatal case of ciprofloxacin-induced fulminant hepatitis. Eur J Case Rep Intern Med. 2020;7:001612. (72 year old man with Waldenstrom’s macroglobulinemia developed dark urine and jaundice 3 days after starting ciprofloxacin for suspected pneumonia [bilirubin 9.2 mg/dL, ALT 1779 U/L, Alk P 234 U/L, protime 15 sec], with rapid progression and death from hepatic failure 46 days after presentation). 32908821
Ahmad W, Waqar M, Hadi MH, Muhammad AS, Iqbal N. Acute cholestatic liver injury due to ciprofloxacin in a young healthy adult. Cureus. 2021;13:e13340. (32 year old woman developed pruritus and jaundice 2 weeks after starting a 10-day course of ciprofloxacin for a urinary tract infection [bilirubin 16.7 mg/dL, ALT 172 U/L, Alk P 866 U/L], biopsy showing cholestatic hepatitis and improvement after stopping ciprofloxacin with normal liver tests 6 weeks later). 33747648
Gu S, Rajendiran G, Forest K, Tran TC, Denny JC, Larson EA, Wilke RA. Drug-induced liver injury with commonly used antibiotics in the All of Us Research Program. Clin Pharmacol Ther. 2023;114:404-412. (Analysis of electronic health records from a large cohort of US subjects [n=318,598] identified 44,202 who received a course of ciprofloxacin, of whom 24 developed liver injury attributable to the drug, yielding a rate of 54 per 100,000 or 1:1,852 persons exposed). 37150941
Mąsior MN, Rostkowska OM, Furmańczyk-Zawiska A, Wieczorek-Godlewska R, Wyzgał M, Durlik M. DRESS syndrome: renal involvement in two cases - a comprehensive analysis and literature review of improved diagnosis and treatment. Am J Case Rep. 2024;25:e942315. (Description of 2 patients with DRESS syndrome, the first an 85 year old woman who developed diarrhea, fever, and rash with edema 4 weeks after stating ciprofloxacin and 3 weeks after starting piperacillin/tazobactam for a surgical site infection [eosinophils 5430/uL, liver tests normal, creatinine 4.2 mg/dL], which resolved slowly after stopping both antibiotics). 38204155

## OTHER REFERENCE LINKS

Recent References on Ciprofloxacin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=ciprofloxacin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222008/07%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Ciprofloxacin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=ciprofloxacin)